# Covid-19 Vaccines

## OVERVIEW

### Introduction

The Severe Acute Respiratory Syndrome Coronavirus type 2 (SARS-CoV-2) is the cause of the pandemic of coronavirus disease (COVID-19) that was first detected in December 2019 in Wuhan, China and subsequently spread globally. By March 2020, COVID-19 was declared a global pandemic and within a year it accounted for more than 100 million cases and 2 million deaths. Also, within a year of its detection, vaccines against SARS-CoV-2 were developed using several methodologies including mRNA-, adenoviral vector- and recombinant DNA-technology. Several of these vaccines have been evaluated in large, placebo-controlled trials and found to be both safe and effective. Adverse events have been mild-to-moderate local reactions and transient systemic symptoms such as fatigue, nausea and headache. After their release and widespread use, however, individual case reports and small case series of serious adverse events began to appear including thrombotic thrombocytopenia, that sometimes involved portal or hepatic vein thromboses and some degree of liver dysfunction, as well as acute liver injury, that often resembled autoimmune hepatitis. Both of these syndromes are rare and it is not clear whether they are coincidental with or a result of the recent COVID-19 vaccination.

### Background

In December 2019, a cluster of cases of severe pneumonia of unknown cause was reported from Wuhan, China that was rapidly shown to be due to a novel coronavirus – the Severe Acute Respiratory Syndrome Corona Virus type 2 (SARS-CoV-2), a virus distantly related to the SARS-CoV [1] agent that caused an epidemic of severe viral pneumonia in 2003 and the Middle East Respiratory Syndrome coronavirus (MERS-CoV) that caused an epidemic of acute respiratory illness in the Middle East in 2012. The SARS-CoV-2 agent proved to be highly contagious, rapidly spreading worldwide, causing outbreaks of severe respiratory illness (COVID-19) and being labelled a pandemic within 4 months of its identification. COVID-19 infection appeared to be symptomatic in over 50% of persons, lead to acute hospitalization in 5% to 10%, and death from respiratory and multiorgan failure in 2%. Major efforts were made to quickly develop means for its control, treatment and prevention, including most importantly, vaccines against COVID-19.

Three major approaches to vaccine development were rapidly successful: mRNA-, adenovirus vector-, and recombinant DNA-based technologies. All have been found to be effective in preventing infection but particularly in preventing severe illness, breakthrough infections usually being asymptomatic or mild-to-moderate in severity. The first two vaccines approved for use in the United States under an Emergency Use Authorization (EUA) were mRNA vaccines – BNT162b2 (Pfizer-BioNTech) and mRNA-1273 (Moderna). Following that, two highly effective adenovirus-based vaccines received emergency use authorization approval in Europe – ChAdOx1.nCoV-19 (Oxford-Astra Zeneca) and the United States – Ad26.COV2.S (Janssen-Johnson & Johnson). A recombinant DNA produced protein vaccine has also been developed and is under clinical evaluation (NVX-CoV2373: Novavax). Furthermore, adenovirus vectored vaccines with reported efficacy have also been developed in Russia (Gam-COVID-Vac, Sputnik-V: ) and China (Ad5 vectored COVID-19 vaccine) where conventional, inactivated viral vaccines have also been produced. COVID-19 vaccines are given by intramuscular injection, and an initial inoculation followed by a second dose 3 to 4 weeks later are recommended for most currently used (see Table below). Booster doses given 6 months after the initial course of two doses are also now being recommended in selected populations. For the Johnson & Johnson COVID-19 vaccine, a booster dose may be given 2 months after the initial single dose to individuals 18 years of age and older.

The COVID-19 vaccines have been found to be generally safe. Common adverse events are mild-to-moderate in severity and self-limiting in course. Immediate local reactions of pain, redness and swelling are most frequent, occurring in 70% to 80% of vaccinees. Mild-to-moderate systemic reactions after 1 to 3 days are also common, occurring in 20% to 40% of vaccinees, and include fatigue, myalgias, headache, nausea and mental fogginess. In contrast, severe immediate, hypersensitivity reactions are rare, but can occur, for which reason a 15 minute period of observation is required after administration of vaccine to allow for prompt treatment of anaphylactic reactions.

Subsequent to the approval, release and widescale use of COVID-19 vaccines, reports of rare but severe adverse events began to appear in individual case reports and small case series. Because these reactions were rare, occurring in 1:100,000 to 1:1,000,000 vaccinated persons and were known to occur spontaneously at low rates, it was difficult to demonstrate that these events were caused or induced by the COVID-19 vaccination rather than arising by chance. Most of the evidence for causality related to the temporal onset of the complication and plausible explanations for the association. Thus, instances of myocarditis, pericarditis, Guillain-Barré syndrome, Bell’s palsy, immune thrombocytopenic purpura, toxic epidermal necrolysis and other syndromes (some associated with minor serum aminotransferase elevations) have been reported arising within days or weeks after vaccination. Yet, in the large controlled trials of the vaccines, these syndromes were not found or they occurred at similar rates with placebo inoculations. In addition, many of these syndromes were found to occur after natural COVID-19 infection, usually at increased rates. Two such syndromes have had clinically apparent hepatic manifestations: (1) vaccine induced thrombotic thrombocytopenia, and (2) vaccine induced autoimmune hepatitis-like injury.

Rare instances of vaccine induced thrombotic thrombocytopenia (VITT) have been described after receipt of COVID-19 vaccines, particularly the adenovirus-based formulations. VITT is characterized by thrombotic episodes in unusual sites (such as the cerebral and splanchnic venous systems) arising 3 to 16 days after an initial dose of vaccine. The syndrome is marked by evidence of platelet activation, antibodies to platelet factor 4 (PF4)-polyanion complexes, and thrombocytopenia – features that are similar to heparin induced thrombotic thrombocytopenia but in the absence of heparin. VITT can be severe and potentially fatal. The frequency of this reaction is estimated to be approximately 1 per million exposures, most commonly in women below the age of 50 years (~7 per million exposures). Instances of severe portal, splenic and mesenteric vein thromboses due to VITT can be accompanied by evidence of mild-to-moderate hepatic injury and dysfunction, typically with serum aminotransferase and alkaline phosphatase elevations without jaundice. The cause of this complication is unknown but may involve induction of platelet activating antibodies due to cross reactivity with antibodies induced by the adenoviral vector or by the modified SARS-CoV-2 spike protein. Importantly, this syndrome appears to respond favorably to intravenous immune globulin (IVIG) infusions and anticoagulation with direct factor IX inhibitors and avoidance of heparin.

The second serious hepatic adverse event that has been linked to COVID-19 vaccination is the appearance of acute liver injury typically with autoimmune features shortly after receipt of a first dose of COVID-19 vaccine. The frequency of this syndrome is not well defined but probably averages no more than 1 per million vaccinees. It was reported initially with mRNA-based COVID-19 vaccines, but subsequently with adenovirus vector-formulations as well. The latency to onset is typically short, in some cases jaundice and symptoms arising within a few days of vaccination. The clinical features often resemble autoimmune hepatitis with marked elevations in serum aminotransferase levels, minimal increases in alkaline phosphatase values and presence of high titers of autoantibodies and elevated immunoglobulin G (IgG) levels (Case 1). Also typical is a protracted course of illness with prompt response to corticosteroid therapy. The long term consequences of this syndrome are unclear as most patients were still receiving immunosuppressive agents at the time of the case reports. Somewhat similar rare instances of autoimmune hepatitis have been reported after other viral vaccines, including against influenza A, and hepatitis A and B. Whether these cases represent vaccine induced or spontaneous autoimmune hepatitis arising in susceptible persons who just happened to receive a vaccine remains unclear. It is also unknown whether this syndrome is self-limited in course, as is typical of most cases of drug induced liver injury with autoimmune features, as opposed to a persistent, long lasting liver injury as is typical of spontaneous autoimmune hepatitis.

The safety and efficacy of the COVID-19 vaccines in pediatric populations are now under evaluation, but both safety and efficacy appear to be similar in adolescents and children as in adults and COVID-19 vaccines for use in younger cohorts are now being approved. Finally, the long term efficacy of currently available vaccines is only partially known, as is the need for future booster injections, particularly using modifications of current vaccine formulations to broaden their efficacy against new, potentially more infectious, virulent and resistant strains of SARS-CoV-2.

### BNT162b2, Tozinameran (Pfizer, BioNTech)

BNT162b2, which has been given the generic name tozinameran and brand name Comirnaty, is a nucleoside-modified mRNA vaccine that encodes the spike protein of SARS-CoV-2, modified in amino acid sequence to keep it in a stable, pre-fusion configuration which is most likely to induce neutralizing antibody. The vaccine was produced rapidly after publication of the SARS-CoV-2 sequence using already established techniques including encapsulation of the mRNA in lipid nanoparticles that protect the mRNA from degradation by plasma RNAse and allow for its rapid uptake into host cells. Two doses of the vaccine (30 µg in 0.3 mL) are recommended, 3 weeks apart. The vaccine requires storage at ultra-low temperatures (-60^o^ to -80^o^ C) and, after thawing, no more than 30 days in temporary storage at 2^o^ to 8^o^ C and thus requires a rigorous cold temperature chain for distribution. In pilot studies, the vaccine was found to be safe and immunogenic. In a large, multinational registration trial in more than 80,000 adults, the vaccine was 57% effective after the initial dose and 95% effective 7 days after the second dose in preventing clinically apparent COVID-19. Studies of large cohorts of adults given the vaccine after its approval demonstrated a similar level of efficacy (greater than 90%) in clinical practice, with similar efficacy rates in all categories of subjects (by age group, gender, race and ethnicity), although slightly lower in patients with multiple comorbidities and immunosuppressed individuals. In studies of cohorts over time, titers of antibody to COVID-19 spike protein were found to decrease, and instances of breakthrough infections were increasingly described. The waning of antibody after vaccination has led to recommendations for booster inoculations 6 months after the two primary inoculations.

Importantly, the BNT162b2 mRNA vaccine was also found to be safe. Mild-to-moderate local reactions (pain, redness, swelling) arise in 70% to 80% of patients and are more frequent in younger subjects and with the second injection. Severe hypersensitivity reactions occurred but were rare (~1 per million recipients), usually arising within 15 minutes of the injection and often in persons with a history of anaphylactic reactions to vaccines. Systemic reactions arising 1 to 3 days after vaccination are also frequent but generally mild-to-moderate in severity and transient in course, occurring in 59% to 70% of persons receiving vaccine vs 34% to 47% receiving placebo. Severe adverse events are rare and most occurrences were judged to be unrelated to the vaccine. There were no deaths attributed to the vaccine and no severe hepatic reactions in the preregistration trials. Since FDA’s emergency use authorization (EUA) of BNT162b2 in December 2020 and approval in August 2021, however, there have been rare reports of hepatic injury arising within days or weeks of receipt of the vaccine. The liver injury is typically hepatocellular and accompanied by high titers of autoantibodies (such as antinuclear antibody or smooth muscle antibody) and elevations in serum immunoglobulin G (IgG) levels and responding rapidly to corticosteroid therapy, as occurs in spontaneous autoimmune hepatitis (Case 1). This syndrome is rare and it is still unclear whether it is due to COVID-19 vaccine or is a coincidental, chance association with spontaneously occurring autoimmune condition due to the frequency of vaccination during the COVID-19 pandemic.

Likelihood score: C (probable, rare cause of clinically apparent liver injury).

### mRNA-1273 (Moderna)

The Moderna COVID-19 vaccine, known as mRNA-1273, is a nucleoside-modified mRNA vaccine that encodes the spike protein of SARS-CoV-2, modified in amino acid sequence to keep it in a stable, pre-fusion configuration most likely to induce neutralizing antibody. The vaccine was produced rapidly after publication of the SARS-CoV-2 sequence using already established techniques including encapsulation of the mRNA of the SARS-CoV-2 spike protein in lipid nanoparticles that protect the mRNA and allow for its rapid uptake into host cells. Two doses of the vaccine (100 µg in 0.5 mL) are recommended, 4 weeks apart. The vaccine requires storage at low temperatures (between -50°C and -15°C), but is stable for up to 30 days after thawing if kept at 2^o^ to 8^o^ C and thus requires a minimally demanding cold chain for distribution. In pilot studies, the vaccine was found to be safe and immunogenic. In a large multinational registration trial in more than 30,000 adults, the vaccine was found to be 94% effective 14 days after the second dose in preventing clinically apparent COVID-19. Studies of large cohorts of adults given the vaccine after its approval and widescale use demonstrated similar level of efficacy (92% to 95%) in clinical practice, with similar efficacy rates across categories of patients (by age group, gender, race, and ethnicity). In study of cohorts over time, antibody titers to the COVID-19 spike protein were found to decrease and booster inoculations 6 months after the primary vaccination (perhaps with half of the initial dose) are now recommended.

The mRNA-1273 COVID-19 vaccine was also shown to be safe. Mild-to-moderate local reactions (pain, redness, swelling) arise in 84% to 89% of patients, being more frequent in younger subjects and with the second injection. Severe hypersensitivity reactions occur but are rare (~2.5 per million), usually arising within 15 minutes of the injection and most frequently in persons with a history of anaphylactic reactions to vaccines. Systemic reactions arising 1 to 3 days after vaccination are also frequent but generally mild-to-moderate in severity, occurring in 55% to 79% of persons. In contrast, severe adverse events are rare and most occurrences were judged to be unrelated to the vaccine. There were no deaths attributed to the vaccine and no severe hepatic reactions reported in the large, initial randomized controlled trials. Since the emergency use authorization of mRNA-1273 in December 2020, however, several reports of an autoimmune-like acute hepatitis have been reported arising within days or weeks of the mRNA-1273 vaccine. The liver injury is typically hepatocellular and accompanied by high titers of autoantibodies (such as antinuclear antibody and smooth muscle antibody) and elevations in serum immunoglobulin G (IgG) levels, and responds rapidly to corticosteroid therapy as occurs in spontaneous autoimmune hepatitis. This syndrome is rare and it is still unclear whether it is due to the mRNA-1623 vaccine or is a coincidental, chance association with this spontaneously occurring autoimmune condition due to the frequency of vaccination during the COVID-19 pandemic.

Likelihood score: C (probable, very rare cause of clinically apparent liver injury).

### ChAdOx1 nCoV-19, AZD1222 (Oxford, AstraZeneca)

ChAdOx1 nCoV-19 vaccine, also known as AZD1222 and now known as Vaxzevria, was developed at Oxford University and licensed to AstraZeneca for production, clinical evaluation and distribution. AZD1222 is an adenovirus vector based vaccine against SARS-CoV-2 infection that has been licensed for use in Europe and Asia and is awaiting U.S. approval. The ChAdOx1 nCoV-19 vaccine employs an infectious but nonreplicating adenovirus to deliver the RNA that encodes the SARS-CoV-2 spike protein in infected cells. This vaccine was rapidly produced soon after publication of the SARS-CoV-2 sequence using already established techniques that were used to develop vaccines for Ebola virus infection. The vaccine is given in two injections of 2.5 x 10^8^ infectious chimpanzee adenoviruses in 0.5 mL 4 to 12 weeks apart. This form of COVID-19 vaccine can be stored at modestly cold temperatures (2^o^ to 8^o^ C) for 6 months. For this reason, ChAdOx1 nCoV-19 vaccine promises to be particularly helpful in medical resource limited areas of the world. Pilot studies demonstrated that the ChAdOx1 nCoV-19 vaccine was safe and effectively induced neutralizing antibody in almost all patients after a single inoculation. In large multinational trials it was found to be 67% effective after two doses in preventing clinically apparent COVID-19 and 87% effective in preventing severe COVID-19 illness. The vaccine was also shown to be safe, although mild-to-moderate local reactions (pain, redness, swelling) arose in 64% of patients, and were more frequent in younger subjects and with the second injection. Severe hypersensitivity reactions occurred but were rare (~1 per million recipients), usually arising within 15 minutes of the injection and often in persons with a history of anaphylactic reactions to vaccines. Systemic reactions arising 1 to 3 days after vaccination were also frequent but generally mild-to-moderate in severity occurring in 22% to 54% of persons. However, severe adverse events were rare and most were judged to be unrelated to the vaccine. In these studies there were no hepatic serious adverse reactions and no deaths attributed to vaccine.

After approval in Europe, however, instances of a severe syndrome of thromboses in unusual sites (cerebral and splanchnic venous system) were reported. The thromboses were accompanied by evidence of activation of platelets, production of antibodies to platelet factor 4 (PF4)-polyanionic complexes and thrombocytopenia, a syndrome similar to heparin induced thrombotic thrombocytopenia, but in the absence of heparin. More than 200 cases of this syndrome have been reported with an estimated frequency is 1 per 100,000 adult recipients, largely among women below the age of 55 among whom the rate is as high as 9 per 100,000 recipients. Referred to as vaccine induced thrombotic thrombocytopenia (VITT), this syndrome has also been encountered after the Ad26.COV2.S vaccine (Janssen, Johnson & Johnson) which was described shortly after its emergency use authorization in the United States. The cause of VITT appears to be the induction of platelet activating antibodies due to production of adenoviral protein-PF4 adducts or molecular mimicry between adenoviral proteins or modified SARS-Co-2 spoke protein and PF4. The thromboses can occur in deep veins in the extremities and in the lungs, sites of typical venous thromboses, but have also been described in unusual sites such as the cerebral venous sinus and splanchnic-portal system. Instances of portal and hepatic vein thromboses have been reported that can be associated with liver test abnormalities and hepatic dysfunction. However, most deaths from VITT have been attributed to intracerebral hemorrhage rather than liver disease or gastrointestinal bleeding. The syndrome appears to respond to therapy with intravenous immune globulin (IVIG), corticosteroids and oral anticoagulants such as the direct factor Xa inhibitors, apixaban or rivaroxaban. Treatment with heparins and coumadin are contraindicated as they appear to exacerbate the problem. Details of the frequency, natural history, specific pathogenesis and management are still under intense study.

Similar to the mRNA vaccines, ChAdOx1 has now been associated with rare instances of clinically apparent liver injury arising within days or weeks of the initial or second vaccine injection. The liver injury is typically hepatocellular and accompanied by autoimmune features such as high titers of autoantibodies (such as antinuclear antibody and smooth muscle antibody) and elevations in serum immunoglobulin G (IgG) levels. The liver injury can be protracted but usually responds rapidly to corticosteroid therapy as occurs in spontaneous autoimmune hepatitis. This syndrome is rare and it is still unclear whether it is due to the ChAdOx1 vaccine or is a coincidental, chance association with this spontaneously occurring autoimmune condition due to the frequency of vaccination during the COVID-19 pandemic.

Likelihood score: C (probable but rare cause of clinically apparent liver injury resembling autoimmune hepatitis or injury resulting from portal vein thrombosis).

### Ad26.COV2.S, JNJ-78436735 (Janssen, Johnson & Johnson)

The Johnson & Johnson COVID-19 vaccine, Ad26.COV2.S, also known as JNJ-78436735, is an adenovirus vector based vaccine against SARS-CoV-2 infection that has been Emergency Use Authorization in the United States on February 27, 2021. The Ad26.COV2.S vaccine employs an infectious but nonreplicating adenovirus to deliver mRNA that encodes the SARS-CoV-2 spike protein to infected cells. This vaccine was rapidly produced soon after publication of the SARS-CoV-2 sequence using already established techniques that were used to develop vaccines for Ebola virus infection. This form of COVID-19 vaccine requires only a single injection and can be kept at modestly cold temperatures of 2^o^ to 8^o^ C for up to 3 months. For this reason, the Ad26.COV2.S vaccine promises to be particularly helpful in medical resource limited areas of the world. Pilot studies demonstrated that the Ad26.COV2.S vaccine was safe and effectively induced neutralizing antibody in a high proportion of patients after a single inoculation. In large multinational studies the vaccine was found to be to be 66% effective 7 days after a single dose in preventing clinically apparent COVID-19 and was 85% effective in preventing severe COVID-19 illness. In follow-up studies of vaccinated cohorts, however, the titers of antibodies to the SARS-CoV-2 spike protein have been found to decrease over time, which appears to underlie the occurrence of breakthrough infections after vaccination. For this reason, booster inoculations (using any of the approved COVID-19 vaccines) are now recommended for recipients of the Ad26.COV2.S vaccine, at least for individuals in high risk groups.

The Ad26.COV2.S vaccine has been shown to be safe. Mild-to-moderate local reactions (pain, redness, swelling) arose in approximately 50% of patients, being more frequent in younger subjects and with the second injection. Severe hypersensitivity reactions occurred but were rare (~1 per million), usually arising within 15 minutes of the injection and often in persons with a history of anaphylactic reactions to vaccines. Systemic reactions arising 1 to 3 days after vaccination were also frequent but generally mild-to-moderate in severity occurring in 30% to 60% of persons. However, severe adverse events were rare and most were judged to be unrelated to the vaccine, although analysis found an excessive of thromboembolic effects in those receiving vaccine, including two cases in young individuals, one with transverse sinus thrombosis.

After approval in the United States in February 2021, however, instances of a severe thrombotic events occurring in unusual sites (cerebral and splanchnic venous system) were reported. The thromboses were accompanied by evidence of activation of platelets, production of antibodies to platelet factor 4 (PF4)-polyanionic complexes and thrombocytopenia, a syndrome similar to heparin induced thrombotic thrombocytopenia, but in the absence of heparin. While venous thromboses were most frequent, arterial thromboses were also reported. The syndrome was often severe and multiple fatalities were reported. Referred to as vaccine induced thrombotic thrombocytopenia (VITT), this syndrome has also been encountered after the ChAdOx1 nCoV-19 (AZD1222) vaccine, with more than 200 cases reported from Europe among approximately 20,000,000 recipients of the vaccine. The incidence of clinically apparent VITT appears to be similar after the Johnson & Johnson Ad26.COV2.S vaccine having been reported in 12 patients among approximately 7 million vaccinees, with the rate in women below the age of 55 being approximately 1 per 100,000. The cause of VITT appears to be the induction of platelet activating antibodies due to molecular mimicry between adenoviral proteins and PF4 or production of adducts of adenoviral DNA or proteins and PF4. The syndrome appears to respond to therapy with intravenous immune globulin (IVIG), corticosteroids and oral anticoagulants such as the direct factor Xa inhibitors, apixaban and rivaroxaban. Treatment with heparin and coumadin are contraindicated as they appear to exacerbate the problem. Details of the frequency, natural history, specific pathogenesis and management are still under intense study.

Thus, Ad26.COV2.S vaccination has not been associated directly with liver test abnormalities or hepatotoxicity or induction of autoimmune hepatitis, but may lead to the rare complication of vaccine induced thrombotic thrombocytopenia which can be associated with portal vein thromboses and liver dysfunction.

Likelihood score: D (possible rare cause of clinically apparent liver injury usually due to portal vein thrombosis).

### NVX-CoV2373 (Novavax)

NVX-CoV2373, also known as Covovax, is a protein subunit vaccine containing recombinant modified SARS-CoV-2 spike glycoprotein in a saponin based matrix adjuvant. The viral vaccine was produced by Novavax using standard recombinant techniques in baculovirus using the viral genome sequence published from China. In pilot studies, NVX-CoV2373 was immunogenic and safe with only mild-to-moderate local and transient systemic adverse reactions. In a large randomized, placebo-controlled trial, the Novavax COVID-19 vaccine was found to be 90% effective in preventing clinically apparent SARS-CoV-2 disease, and adverse event rates were similar to those reported for other COVID-19 vaccines. Thus, overall adverse event rates were higher among NVX-CoV2373 than placebo recipients, but serious adverse event rates were similar and less than 1%. Importantly, the vaccine is stable at temperatures of 2^o^ to 8^o^ C for several months and would be valuable for distribution in resource limited countries of the world. The Novavax COVID-19 vaccine has yet to receive approval in the United States. There have been no reports of hepatic adverse events attributed to NVX-CoV2373, although the total clinical experience with the vaccine is limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Gam-COVID-Vac, Sputnik-V (Gamaleya National Center, Russia)

Gam-COVID-Vac or Sputnik-V is a heterologous adenoviral vector based vaccine against SARS-CoV-2 infection that uses two different adenoviruses (rAd26-S and rAd5-S), both being infectious but nonreplicating human adenoviruses that deliver the RNA that encodes the SARS-CoV-2 spike protein to infected cells. The initial vaccine dose uses the rAd26-S vector and the second the rAd5-S vector, thereby avoiding possible neutralization by antibody responses to the initial adenovirus vector injection. This vaccine was developed at the Gamaleya National Center of Epidemiology and Microbiology in Moscow soon after publication of the SARS-CoV-2 sequence using already established techniques that were used to develop vaccines for Ebola virus infection. In pilot studies, the vaccine was shown to be safe and immunogenic. In a large multicenter trial in 21,977 adults, the Sputnik-V vaccine was found to be 92% effective from the time of the second dose in preventing clinically apparent COVID-19 and 100% effective in preventing severe cases. The vaccine was also safe, although mild-to-moderate local reactions (pain, redness, swelling) arose in 70% to 80% of patients. Systemic reactions such as fever, headache and fatigue arising 1 to 3 days after vaccination were also frequent but generally mild-to-moderate in severity occurring in 30% to 50% of persons. However, severe adverse events were rare and were no more frequent in vaccine vs placebo recipients. There were no deaths attributed to the vaccine and no severe hepatic reactions. Since approval of Sputnik-V in Russia and distribution elsewhere in the world, there have been no reports of severe adverse events or hepatotoxicity associated with its use. While Sputnik-V is an adenoviral vector based vaccine like the AstraZeneca ChAdOx1 nCOV-19 and the Johnson and Johnson Ad26.COV2.S COVID-19 vaccines, it has not been linked to cases of thrombotic thrombocytopenia that has been reported with the other adenoviral vector based COVID vaccines. Thus, liver injury from the Sputnik-V must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Sinopharm COVID-19 Vaccine (Sinopharm, Beijing) and Corona Vac (Sinovac)

At least 5 different COVID-19 vaccines have been developed and approved for use in China including adenovirus vector based vaccines as well as conventional inactivated viral vaccines. For most there is little published on their efficacy and safety. Two of these vaccines (one from Sinopharm and another from Sinovac) have been approved by the World Health Organization as a part of their worldwide COVID-19 vaccination global initiative called COVAX. Central to the Chinese plan to vaccinate the majority of its citizens by 2022 are the Sinopharm, Beijing, and Sinovac Corona Vac vaccines, both of which are conventional inactivated viral vaccines. Results of clinical trials of their safety and efficacy from different areas of the world have claimed efficacy rates ranging from 50% to 91% in preventing symptomatic COVID-19 after two doses. These vaccines are also being used in multiple other countries including Indonesia, Pakistan, Russia, Turkey, Egypt, Jordan, the United Arab Emirates, Morocco, Brazil, Chile, Argentina, Peru and Mexico. The spectrum and frequency of adverse events following the Sinopharm and Sinovac COVID-19 vaccines have not been published, but the means of production would suggest that these vaccines are relatively safe and unlikely to cause liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism(s) by which COVID-19 vaccines might cause serum enzyme elevations or clinically apparent liver injury is not known. The breakdown of mRNA and recombinant proteins occurs intracellularly and results in the release of polypeptides, amino acids and nucleic acids none of which should cause hepatic injury. In cases of vaccine induced thrombotic thrombocytopenia, portal and hepatic vein thromboses might induce some degree of hepatic dysfunction, but the thromboses and bleeding elsewhere are likely to overshadow any liver injury. The autoimmune hepatitis that has been described after COVID-19 vaccination has been linked to both mRNA and adenovirus based vaccines. It is unclear whether the autoimmune hepatitis is triggered by the vaccine or is a coincidental occurrence.

### Outcome and Management

Patients who receive COVID-19 vaccines should be encouraged to report any new major symptoms or signs that arise within a month after vaccination. Patients who receive adenoviral vectored vaccines should be informed of the possibility of thrombotic events arising 5 to 16 days after administration (usually with the first dose) and investigated rapidly for the possibility of thrombotic thrombocytopenia.

## CASE REPORT

### Case 1. Acute liver injury after COVID-19 vaccination.(1)

A 35 year old woman developed an acute hepatitis with autoimmune features 1 to 2 weeks after receiving a first dose of the Pfizer BNT162b2 COVID-19 vaccine. She was in general good health and was 3 months postpartum. Approximately one week after receiving the COVID-19 vaccine, she developed pruritus followed by dark urine and then jaundice. She had no history of liver disease and her only medications were labetalol which had been started for gestation hypertension and was continued after delivery. She denied taking other medications including over-the-counter agents and herbal supplements. When seen in an emergency room approximately 13 days after vaccination, she was jaundiced and had mild hepatomegaly. Laboratory testing showed a total bilirubin of 4.8 mg/dL, ALT 2001 U/L, AST 754 U/L, and alkaline phosphatase 170 U/L. Tests for hepatitis A, B and C were negative as were tests for EBV, CMV, HSV1 and 2, and HIV infection. The ANA was strongly positive (1:1280) as were antibodies to double stranded DNA, while SMA, anti-LKM, ANCA and AMA were negative. Abdominal ultrasound was unremarkable, and endoscopic ultrasound showed no evidence of gallstones or biliary obstruction. A liver biopsy showed changes suggestive of autoimmune hepatitis with portal and lobular inflammation, focal necrosis, rosette formation, and marked interface hepatitis with lymphocytes, plasma cells and eosinophils. There was scant fibrosis and no evidence of cirrhosis.

Over the first few hospital days, serum bilirubin remained elevated and aminotransferase levels fluctuated, decreasing minimally (Table). Because of the autoantibodies and liver histology suggestive of an autoimmunity, prednisone [20 mg daily] was started. There was prompt improvement and when she was seen as an outpatient several weeks later, she was asymptomatic and liver tests were normal. The dose of prednisone was lowered and then stopped. Six weeks after stopping she remained asymptomatic and liver tests were normal.

#### Key Points

Medication: | Pfizer BNT162.b2 COVID-19 vaccine
Pattern: | Hepatocellular (R=38)
Severity: | 3+ (enzyme elevations, jaundice and hospitalization)
Latency: | 7 days to onset of symptoms, 13 days to presentation
Recovery: | Within 2 months, on prednisone
Other medications: | Labetalol (100 mg twice daily) for ~8 months

#### Laboratory Values

Time After Vaccine | Time After Presentation | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Comments
13 days | 0 | 2001 | 170 | 4.8 | Emergency Room
14 days | 1 day | 1746 | 183 | 5.7 | Admission, Ultrasound
15 days | 2 days | 1629 | 171 | 5.4
16 days | 3 days | 1898 | 181 | 5.9 | Liver Biopsy
17 days | 4 days | 1832 | 178 | 6.8
18 days | 5 days | 1375 | 153 | 6.0
19 days | 6 days | 1462 | 162 | 4.9 | Prednisone started, discharge
24 days | 11 days | 501 | 127 | 1.6 | Prednisone 20 mg/day*
2 months | 6 weeks | 19 | 63 | 0.6 | Prednisone 15 mg/day*
| 4 months | 17 | 57 | 0.6 | Prednisone 10 mg/day*
| 6 months | 16 | 55 | 0.3 | Prednisone 5 mg/day: stopped*
| 8 months | 13 | 67 | 0.4 | Off of prednisone for 7 weeks*
Normal Values | | <52 | <117 | <1.2

* Values and prednisone doses provided by Dr. Bril.

#### Comment

This was the initial case report of acute hepatitis with autoimmune features following and possibly caused by COVID-19 vaccination. After this publication, another dozen instances arising after mRNA- as well as adenovirus vector-based vaccines were soon reported in letters to the editor from around the world. Characteristic of the injury was the marked hepatocellular pattern of enzyme elevations, mild jaundice, presence of autoantibodies in high titer, an accompanying hypergammaglobulinemia, and histologic features of an acute, florid autoimmune hepatitis. Also characteristic was the rapid response to corticosteroid therapy. In this case, a prudent dose of prednisone was used, which was then tapered and ultimately discontinued. In follow up, the patient remained in remission, although further monitoring would be appropriate, as late relapses can occur after stopping immunosuppression in patients with typical spontaneous autoimmune hepatitis. A central question is whether the episode represented vaccine induced liver injury with autoimmune features, or an autoimmune hepatitis triggered by the viral vaccine, or a coincidental occurrence of spontaneous autoimmune hepatitis that happened to become clinically evident shortly after vaccination (and a few months after pregnancy). The clinical features were typical of autoimmune hepatitis. Whether autoimmune hepatitis is triggered by COVID-19 vaccination will require more experience with this complication as well as genetic and immunologic studies aimed at how vaccines stimulate autoimmunity. Thus, features of this syndrome suggest that the pathogenesis is [underlined: indirect], caused by modulation of the immune system rather than direct although idiosyncratic injury to hepatocytes.

COVID-19 Vaccines: Status in the United States

Vaccine Platform | Vaccine Name | Manufacturer | U.S. Status Date | No. Shots | Efficacy | Likelihood Score | Comments
BNT162b2; [mRNA] | Comirnaty | Pfizer; BioNTech | Approved; Aug 2021 | 2; [21 d] | 95% | C | Ultra-low cold chain; [-60^o^ to -80^o^]; Autoimmune hepatitis
mRNA-1273; [mRNA] | CX-024414 | Moderna | EUA; Dec 2020 | 2; [28 d] | 94% | C | Moderate cold chain [-15^o^ to 25^o^]. Autoimmune hepatitis
Ad26.COV2.S; [adenoviral vector] | JNJ-78436735 | Johnson & Johnson Janssen | EUA; Feb 2021 | 1 | 66-72% | D | Thrombotic thrombocytopenia
ChAdOx1 nCoV-19; [adenoviral vector] | AZD1222; Vaxzevria | AstraZeneca; Oxford | Pending | 2; [28-84 d] | 55-82% | C | Thrombotic thrombocytopenia
NVX-CoV2373; [recombinant protein] | Covovax | Novavax | Pending | 2; [21 d] | 90% | E | 60% effective for B.1.351, Adjuvant
Gam-COVID-Vac; [adenoviral vectors] | Sputnik V | Gamaleya; Russia | None | 2; [21 d] | 92% | E | rAd26-S, rAd5-S
Sinopharm; [inactivated virus] | Beijing; Wuhan | SInopharm; China | None | 2 | 78-86% | E | Global distribution
Sinovac; [inactivated virus] | Corona Vac | Sinovac; China | None | 2 | 50-66% | E | Global distribution

Table Updated September 26, 2021

Drug Class: Antiviral Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

BNT162b2 – Comirnaty®

mRNA-1273 – Moderna COVID-19 Vaccine®

Ad26.COV2.S – JNJ-78436735®

ChAdOx1 nCoV-19 – Vaxzevria®

NVX-CoV2373 – Covovax®

DRUG CLASS

Antiviral Vaccines

## CITED REFERENCE

1 Bril F, Al Diffalha S, Dean M, Fettig DM. (2021). Autoimmune hepatitis developing after coronavirus disease 2019 (COVID-19) vaccine: Causality or casualty?. J Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 28 October 2021

Abbreviation: AMA, antimitochondrial antibody; ANA, antinuclear antibody; EUA, Emergency Use Authorization; IgG, immunoglobulin G; IVIG, intravenous immune globulin; PF-4, platelet factor 4; SMA, smooth muscle antibody; VITT, vaccine induced thrombotic thrombocytopenia.

CDC. https://www.cdc.gov/vaccines/covid-19/info-by-product/index.html (CDC website on COVID-19 vaccines available in the US with links to documents from the FDA summarizing efficacy and safety data that supported the EUAs for the Pfizer, Moderna, and Johnson & Johnson COVID-19 vaccines).
Zhu N, Zhang D, Wang W, Li X, Yang B, Song J, Zhao X, et al. (2020). China novel coronavirus investigating and research team. A novel coronavirus from patients with pneumonia in China, 2019. N Engl J Med. (In December 2019, a cluster of patients with severe pneumonia of unknown cause was linked to a seafood wholesale market in Wuhan, China, and was found to be due to a novel coronavirus).
Huang C, Wang Y, Li X, Ren L, Zhao J, Hu Y, Zhang L, et al. (2020). Clinical features of patients infected with 2019 novel coronavirus in Wuhan, China. Lancet. (Among 41 adults with COVID-19 pneumonia hospitalized in Wuhan China in December 2019-January 2020, 37% had serum AST elevations [62% of those in the ICU and 25% of those not] with concurrent elevations in proinflammatory cytokines [IL1B, IL6, IL2, IFN gamma] and 15% died).
Guan WJ, Ni ZY, Hu Y, Liang WH, Ou CQ, He JX, Liu L, et al. (2020). China Medical Treatment Expert Group for Covid-19. Clinical characteristics of coronavirus disease 2019 in China. N Engl J Med. (Among 1099 patients hospitalized with COVID-19 at 552 hospitals in China through January 2020, the median age was 47 years, 42% were women, 2.4% were admitted to an ICU, 1.4% died and ALT elevations arose in 4.1%).
Jackson LA, Anderson EJ, Rouphael NG, Roberts PC, Makhene M, Coler RN, McCullough MP, et al. (2020). mRNA-1273 Study Group. An mRNA vaccine against SARS-CoV-2 - preliminary report. N Engl J Med. (In a phase 1 dose finding study of the mRNA-1273 COVID-19 vaccine, 45 adults [ages 18 to 55 years] were given 2 injections of one of 3 doses of vaccine [25, 100, or 250 µg] 28 days apart, and resultant geometric mean titers of anti-SARS-CoV-2 after the 2^nd^ injection were higher with higher doses, but all subjects developed neutralizing antibody and adverse events were more frequent and sometimes severe with the 250 µg dose; no mention of ALT elevations or hepatotoxicity).
Zhu FC, Guan XH, Li YH, Huang JY, Jiang T, Hou LH, Li JX. (2020). Yet al. Immunogenicity and safety of a recombinant adenovirus type-5-vectored COVID-19 vaccine in healthy adults aged 18 years or older: a randomised, double-blind, placebo-controlled, phase 2 trial. Lancet. (Among 508 adults who received one of two doses of Ad5-vectored COVID-19 vaccine or placebo, seroconversion rates at day 28 were 96-97% and there were no serious adverse events).
Corbett KS, Flynn B, Foulds KE, Francica JR, Boyoglu-Barnum S, Werner AP, Flach B, et al. (2020). Evaluation of the mRNA-1273 vaccine against SARS-CoV-2 in nonhuman primates. N Engl J Med. (24 young rhesus macaques received one of two doses of mRNA-1273 [10 or 100 µg] or control diluent and were challenged with live SARS-CoV-2 4 weeks after the 2^nd^ injection when the vaccinated animals had high levels of antibody to the SARS-CoV-2 spike protein, which resulted in active infection and evidence of respiratory disease in controls but either no infection or a mild, subclinical infection with minimal viral RNA detected in the vaccinated animals).
Keech C, Albert G, Cho I, Robertson A, Reed P, Neal S, Plested JS, et al. (2020). Phase 1-2 trial of a SARS-CoV-2 recombinant spike protein nanoparticle vaccine. N Engl J Med. (Among 131 adults vaccinated with 5 or 25 µg of NVX CoV2373 vaccine with or without adjuvant or placebo, titers of IgG anti-SARS-CoV-2 spike protein were achieved after the second dose of vaccine with adjuvant at levels equivalent to those achieved after natural infection and adverse events were common but mild and transient, mostly local reactions and a few days of system symptoms of fatigue and myalgia; ALT elevations arose in 3 of 108 receiving vaccine and 1 of 23 placebo, but all were transient and less than 3 times ULN).
Anderson EJ, Rouphael NG, Widge AT, Jackson LA, Roberts PC, Makhene M, Chappell JD, et al. (2020). mRNA-1273 Study Group. Safety and immunogenicity of SARS-CoV-2 mRNA-1273 vaccine in older adults. N Engl J Med. (Among 40 adult volunteers ages 56 years and above who received one of two doses [25 or 100 µg] of the mRNA-1273 COVID-19 vaccine, geometric mean titers after the second injection were higher in older subjects [>70 years] and with the higher vaccine dose, but all patients developed neutralizing antibody at levels equal to or above those occurring after natural infection; adverse events were largely transient, mild-to-moderate local pain and systemic symptoms of fatigue, headache, muscle ache and chills lasting 1-5 days; there were no serious adverse events and no mention of ALT elevations or hepatotoxicity).
Zhang Y, Zeng G, Pan H, Li C, Hu Y, Chu K, Han W, et al. (2021). Safety, tolerability, and immunogenicity of an inactivated SARS-CoV-2 vaccine in healthy adults aged 18-59 years: a randomised, double-blind, placebo-controlled, phase 1/2 clinical trial. Lancet Infect Dis. (Among 743 adults who received at least one dose of the Corona Vac inactivated COVID-19 vaccine in phase 1 and phase 2 trials, adverse reactions were generally mild and the seroconversion rate after two doses was 97-100%; no mention of hepatic adverse events).
Ramasamy MN, Minassian AM, Ewer KJ, Flaxman AL, Folegatti PM, Owens DR, Voysey M, et al., Oxford COVID Vaccine Trial Group. (2021). Safety and immunogenicity of ChAdOx1 nCoV-19 vaccine administered in a prime-boost regimen in young and old adults (COV002): a single-blind, randomised, controlled, phase 2/3 trial. Lancet. (Among 552 adults in 3 age groups [18 to 59, 60 to 70, >70 years] given the ChAdOx1 nCoV-19 vaccine or a control viral vaccine, local and systemic adverse events were more frequent with the COVID-19 vaccine and among the younger age groups, whereas IgG anti-spike antibody, neutralizing antibody and T cell responses were similarly high among all age groups).
Guebre-Xabier M, Patel N, Tian JH, Zhou B, Maciejewski S, Lam K, Portnoff AD, et al. (2020). NVX-CoV2373 vaccine protects cynomolgus macaque upper and lower airways against SARS-CoV-2 challenge. Vaccine. (The COVID-19 subunit vaccine NVX-CoV2373 with full length recombinant SARS-CoV-2 spike glycoprotein in a saponin based matrix adjuvant in initial and booster doses of 2.5, 5 and 5 µg induced neutralizing antibody in Cynomolgus macaques and protected animals against both infection and disease after viral challenge).
Polack FP, Thomas SJ, Kitchin N, Absalon J, Gurtman A, Lockhart S, Perez JL, et al. (2020). C4591001 Clinical Trial Group. Safety and efficacy of the BNT162b2 mRNA Covid-19 vaccine. N Engl J Med. (Among 43,448 persons receiving the BNT162b2 vaccine or placebo, COVID-19 was diagnosed more than 7 days after the second inoculation in 8 receiving vaccine and 162 placebo for an efficacy of 95%; while adverse events were largely mild-to-moderate in severity and self-limited in course, local pain at the injection site occurred in 71-83% [vs 9-14% with placebo] and systemic effects of fatigue in 47% vs 33%, being more frequent in younger subjects and with the second injection; there were no serious hepatic adverse events and no vaccine related deaths).
Baden LR, El Sahly HM, Essink B, Kotloff K, Frey S, Novak R, Diemert D, et al., COVE Study Group. (2021). Efficacy and safety of the mRNA-1273 SARS-CoV-2 vaccine. N Engl J Med. (Among 30,420 adults given two injections [4 weeks apart] of the mRNA-1273 vaccine or placebo, COVID-19 illness arose 14 days after the second injection in 11 receiving vaccine vs 185 receiving placebo for an efficacy rate of 94.1% with similar rates across different groups by sex, age, race and ethnicity, while adverse events arose in 84% vs 20% and were more common in younger patients and with the 2^nd^ vaccine inoculation, but serious adverse event rates were similar in both groups, and there were no liver related serious adverse events or deaths attributable to vaccine).
Callaway E, Mallapaty S. (2021). Novavax offers first evidence that COVID vaccines protect people against variants. Nature. (A commentary reporting results from 2 efficacy trials of the Novavax COVID-19 vaccine, one in 15,000 subjects in the UK and another in 4,400 subjects in South Africa, found the vaccine efficacy to be 86% against the UK variant B.1.1.7 but only 50% effective against the South African variant 501Y.V2).
(2021). FDA authorizes Moderna COVID-19 vaccine. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of the Moderna mRNA-1723 COVID-19 vaccine shortly after its EUA on December 18, 2020, mentions that its approval was based on a multinational observer blind trial in 30,420 adults given two doses four weeks apart that was 94% effective overall and 100% effective in preventing severe COVID-19; no mention of hepatic adverse events).
(2021). FDA authorizes Pfizer-BioNTech COVID-19 vaccine. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of the Pfizer-BioNTech BNT162b2 COVID-19 vaccine shortly after its EUA on December 11, 2020 mentions that its approval was based on a multinational double-blind trial in 43,548 subjects given two doses 3 weeks apart that was 95% effective overall; no mention of hepatic adverse events).
Logunov DY, Dolzhikova IV, Shcheblyakov DV, Tukhvatulin AI, Zubkova OV, Dzharullaeva AS, Kovyrshina AV, et al., Gam-COVID-Vac Vaccine Trial Group. (2021). Safety and efficacy of an rAd26 and rAd5 vector-based heterologous prime-boost COVID-19 vaccine: an interim analysis of a randomised controlled phase 3 trial in Russia. Lancet. (Among 14,964 adults receiving one of two doses of Gam-COVID-Vac [Sputnik V: rAd26 in first and rAd5 in the second] and 4,902 placebo controls, 16 vaccinated [0.1%] vs 62 controls [1.3%] developed symptomatic COVID-19 illness after the last vaccine dose for an efficacy rate of 92%; most adverse events were mild-to-moderate in severity and of short duration and serious adverse events occurred at a similar rate in vaccine [0.3%] and control [0.4%] recipients, with no serious hepatic adverse events).
Voysey M, Costa Clemens SA, Madhi SA, Weckx LY, Folegatti PM, Aley PK, et al., Oxford COVID Vaccine Trial Group. (2021). Single-dose administration and the influence of the timing of the booster dose on immunogenicity and efficacy of ChAdOx1 nCoV-19 (AZD1222) vaccine: a pooled analysis of four randomised trials. Lancet. (In a pooled analysis of 4 trials of the ChAdOx1 nCoV-19 vaccine, 17,178 adults received vaccine or control and efficacy measured two weeks after 2^nd^ dose was 66.7% with 84/8547 [1%] of vaccinated vs 248/8581 [2.9%] of controls developing symptomatic COVID-19, but none of the vaccinated versus 15 of the controls required hospitalization for COVID; serious adverse event rates were similar in the two groups [0.9% vs 1.1%] and there were no serious hepatic adverse events).
Dagan N, Barda N, Kepten E, Miron O, Perchik S, Katz MA, Hernán MA, et al. (2021). BNT162b2 mRNA Covid-19 vaccine in a nationwide mass vaccination setting. N Engl J Med. (Among 596,618 recipients of the BNT162b2 Pfizer COVID-19 vaccine and a similar number of unvaccinated controls in Israel, the calculated efficacy after the first dose was 46% and was 92% 7 days after the second dose).
Stephenson KE, Le Gars M, Sadoff J, de Groot AM, Heerwegh D, Truyers C, Atyeo C, et al. (2021). Immunogenicity of the Ad26.COV2.S vaccine for COVID-19. JAMA. (Pilot study in 25 adults given the AD26.COV2.S Johnson & Johnson COVID-19 vaccine in 2 doses 57 days apart found neutralizing antibody developed in all subjects after a single inoculation and T cell response in 84%).
Boyarsky BJ, Werbel WA, Avery RK, Tobian AAR, Massie AB, Segev DL, Garonzik-Wang JM. (2021). Immunogenicity of a single dose of SARS-CoV-2 messenger RNA vaccine in solid organ transplant recipients. JAMA. (Among 658 solid organ transplant recipients who received two doses of an mRNA COVID-19 vaccine, only 54% developed detectable antibody to SARS-CoV-2 spike protein, suggesting low levels of protection in immunosuppressed transplant recipients; no mention of adverse events).
Schultz NH, Sørvoll IH, Michelsen AE, Munthe LA, Lund-Johansen F, Ahlen MT, Wiedmann M, et al. (2021). Thrombosis and thrombocytopenia after ChAdOx1 nCoV-19 vaccination. N Engl J Med. (Description of 5 health care workers [4 women, 1 man, ages 32 to 54 years] who developed thromboses in unusual sites [brain, splanchnic bed] and thrombocytopenia 7-10 days after receipt of initial dose of ChAdOx1 vaccine [Astra-Zeneca], all of whom had high levels of antibodies to platelet factor 4 [PF4]-polyanionic complexes, 3 of whom died, others seeming to respond to IVIG and prednisolone, referring to the syndrome as vaccine induced thrombotic thrombocytopenia [VITT]).
Greinacher A, Thiele T, Warkentin TE, Weisser K, Kyrle PA, Eichinger S. (2021). Thrombotic thrombocytopenia after ChAdOx1 nCov-19 vaccination. N Engl J Med. (Description of 11 patients [9 women, 2 men, ages 22 to 49 years] who developed thrombotic events in unusual sites [9 cerebral, 3 splanchnic] with symptomatic presentation 5-16 days after an initial dose of ChAdOx1 AstraZeneca COVID-19 vaccine, 6 of whom died due to cerebral complications, all having antibodies to platelet factor 4 [PF4]-polyanionic complexes independent of heparin and with evidence of platelet activation and thrombocytopenia; one patient developed portal vein thrombosis and had elevations in serum ALT [peak 167 U/L], GGT [110 U/L] and LDH [337 U/L], but bilirubin not reported).
Cines DB, Bussel JB. (2021). SARS-CoV-2 vaccine-induced immune thrombotic thrombocytopenia. N Engl J Med. (Editorial in response to Schultz [2021] and Greinacher [2021] summarizing the clinical and laboratory features, possible pathogenesis and management of vaccine induced thrombotic thrombocytopenia [VITT] apparently triggered by receipt of adenovirus based COVID-19 vaccines).
Kumar A, Dowling WE, Román RG, Chaudhari A, Gurry C, Le TT, Tollefson S, et al. (2021). Status report on COVID-19 vaccines development. Curr Infect Dis Rep. (Review of the status of COVID-19 vaccines, over 300 of which are under development and at least 6 approved for emergency use including mRNA-based candidates [7 in clinical trials and 2 approved], DNA based [6 being tested], protein based [at least 20 in clinical trials but none approved as yet], and viral vector based [15 in clinical trials and 4 approved]).
Sadoff J, Gray G, Vandebosch A, Cárdenas V, Shukarev G, Grinsztejn B, Goepfert PA, et al., ENSEMBLE Study Group. (2021). Safety and efficacy of single-dose Ad26.COV2.S vaccine against Covid-19. N Engl J Med. (In a multinational randomized controlled trial of a single injection of the Ad26.COV2.S adenovirus based vaccine, symptomatic COVID-19 illness arose at least 2 weeks after the injection in 116 of 19630 vaccinated subjects [0.6%] vs 348 placebo recipients [1.8%] for a 67% efficacy rate, while vaccine adverse events included injection site pain in 49%, headache 39%, fatigue 38%, myalgia 33% and nausea 14%, and while serious adverse event rates were similar in the two groups [0.4%vs 0.4%], there were an excess of venous thrombotic events after vaccine [11 vs 3 events] and one case of transverse sinus thrombosis).
(2021). FDA authorizes Johnson & Johnson COVID-19 vaccine. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of the Johnson & Johnson Ad26.COV2.S COVID-19 vaccine shortly after its EUA on February 27, 2021 mentions that its approval was based on a multinational trial in 44,325 patients given a single dose that was 66% effective overall and 85% effective in preventing severe COVID-19; no mention of hepatic adverse events).
See I, Su JR, Lale A, Woo EJ, Guh AY, Shimabukuro TT, Streiff MB, et al. (2021). US case reports of cerebral venous sinus thrombosis with thrombocytopenia after Ad26.COV2.S vaccination, March 2 to April 21, 2021. JAMA. (Vaccine adverse event reports made between February 27 and April 12, 2021 included 12 cases of thrombotic thrombocytopenia arising 6-15 days after receipt of the Ad26.COV2.S Johnson & Johnson COVID-19 vaccine among an estimated 7 million recipients, all in women, ages 18 to 60 years presenting with headache, all with antibodies to PF4-polyanionic complexes usually with cerebral sinus thromboses and at least 3 deaths).
Bril F, Al Diffalha S, Dean M, Fettig DM. (2021). Autoimmune hepatitis developing after coronavirus disease 2019 (COVID-19) vaccine: Causality or casualty?. J Hepatol. (35 year old woman developed fatigue followed by jaundice 1-2 weeks after receiving the Moderna COVID-19 mRNA 1273 vaccine [bilirubin 4.8 mg/dL, ALT 2001 U/L, Alk P 170 U/L, ANA 1:1200], with biopsy suggesting autoimmune hepatitis and prompt response to corticosteroid therapy: Case 1).
Berry PA, Smith-Laing G. (2007). Hepatitis A vaccine associated with autoimmune hepatitis. World J Gastroenterol. (56 year old man had an unexplained, self-limited acute hepatitis with full recovery without treatment, but then had a relapse, 10 days after receiving hepatitis A vaccine [bilirubin not given, AST 1684 U/L, INR 1.4], which remained active for 3 months at which time ANA became positive [1:100] and total globulins were elevated [4.7 g/dL], biopsy was compatible with autoimmune hepatitis and liver tests improved rapidly with prednisolone therapy).
Perumalswami P, Peng L, Odin JA. (2009). Vaccination as a triggering event for autoimmune hepatitis. Semin Liver Dis. (31 year old woman developed nausea and dark urine 11 days after hepatitis A and yellow fever vaccination and shortly after returning from a trip to Africa [bilirubin 9.4 mg/dL, ALT 515 U/L, Alk P 162 U/L, ANA negative, IgG 1870 mg/dL], with subsequent worsening and liver biopsy compatible with autoimmune hepatitis and subsequent improvement with prednisone therapy and later stopped but then restarted despite normal liver tests).
van Gemeren MA, van Wijngaarden P, Doukas M, de Man RA. (2017). Vaccine-related autoimmune hepatitis: the same disease as idiopathic autoimmune hepatitis? Two clinical reports and review. Scand J Gastroenterol. (Two cases of autoimmune hepatitis arising within 2-4 weeks of vaccination against hepatitis A, but with multiple other vaccines, 22 and 28 year old women [initial bilirubin 13 and 10.2 mg/dL, ALT 1751 and 1027 U/L, Alk P 165 U/L and unknown, ANA negative in one, positive in one], biopsies suggesting autoimmune hepatitis and prompt response to prednisone, but relapse on stopping 6 months later, both requiring long term immunosuppressive therapy).
Sasaki T, Suzuki Y, Ishida K, Kakisaka K, Abe H, Sugai T, Takikawa Y. (2018). Autoimmune hepatitis following influenza virus vaccination: Two case reports. Medicine (Baltimore). (Two women, ages 31 and 49 years, developed liver test abnormalities 11 days and 1 month after influenza vaccination [bilirubin levels not provided, ALT 61 and 280 U/L, Alk P 399 and 320 U/L, ANA positive [both 1:320], IgG 3453 and 1706 mg/dL], biopsies compatible with autoimmune hepatitis and both had improvements with prednisone therapy which was then continued in follow up).
Muratori P, Serio I, Lalanne C, Lenzi M. (2019). Development of autoimmune hepatitis after influenza vaccination; trigger or killer?. Clin Res Hepatol Gastroenterol. (78 year old man developed abdominal pain followed by dark urine within 10 days of influenza vaccination [bilirubin 18.8 mg/dL, ALT 1575 U/L, ANA 1:320, SMA 1:640, IgG 2,334 mg/dL, INR 1.3], biopsy compatible with autoimmune hepatitis and improvement with methylprednisolone therapy).
Testino G, Pellicano R. Acute on chronic liver failure by SARS-CoV-2 in active alcohol use disorder cirrhotic patient: a case report. Minerva Gastroenterol (Torino). 2021 May 10. Epub ahead of print. (56 year old man with alcohol related cirrhosis and mild decompensation developed severe COVID-19 pneumonia which progressed to ventilatory failure, the course being accompanied by worsening of the liver disease [bilirubin 2.0 rising to 22.0 mg/dL, ALT 35 to 90 U/L, Alk P 132 to 150 U/L, INR 1.9 to 3.1] and accompanying multiorgan failure and death 14 days after presentation).
Umbrello M, Brena N, Vercelli R, Foa RA, Femia M, Rossi U, Podda GM, et al. (2021). Successful treatment of acute spleno-porto-mesenteric vein thrombosis after ChAdOx1 nCoV-19 vaccine. A case report. J Crit Care. (36 year old woman developed abdominal pain 7 days after Astra Zeneca ChAdOx1 COVID-19 vaccine, imaging showing thrombosis of splenic, portal and superior mesenteric veins which was successfully treated with IVIG, argatroban, and direct thrombolysis and balloon angioplasty of the portal vein).
Ge J, Pletcher MJ, Lai JC; N3C Consortium. Outcomes of SARS-CoV-2 infection in patients with chronic liver disease and cirrhosis: a national COVID cohort collaborative study. Gastroenterology. 2021:S0016-5085(21)03244-3. (Analysis of 6.4 million electronic medical records for presence of chronic liver disease, cirrhosis and COVID-19 status, found 30-day mortality was increased in those with COVID-19 positivity both in those without cirrhosis [1.7% vs 0.8%] and even more in those with cirrhosis [8.9% vs 1.7%]).
Hines A, Shen JG, Olazagasti C, Shams S. (2021). Immune thrombocytopenic purpura and acute liver injury after COVID-19 vaccine. BMJ Case Rep. (26 year old woman developed petechial rash and thrombocytopenia [19,000/µL] 2 weeks after receiving the Moderna mRNA1273 COVID-19 vaccine [bilirubin 1.0 rising to 1.9 mg/dL, ALT 707 rising to 1257 U/L, Alk P 82 U/L], with prompt response of platelet count to corticosteroid therapy).
Öcal O, Stecher SS, Wildgruber M. (2021). Portal vein thrombosis associated with ChAdOx1 nCov-19 vaccination. Lancet Gastroenterol Hepatol. (41 year old man developed severe headache 11 days after receiving Astra Zeneca ChAdOx1 COVID-19 vaccine, but head CT showed no thrombus, but 4 days later he had onset of severe abdominal pain and CT showed thrombus in portal system with subsequent splenic rupture requiring splenectomy and mechanical aspiration of the thrombus, which resulted in canalization of the portal vein).
Rocco A, Sgamato C, Compare D, Nardone G. (2021). Autoimmune hepatitis following SARS-CoV-2 vaccine: May not be a casuality. J Hepatol. (80 year old woman [with a history of Hashimoto’s thyroiditis] developed jaundice 1 week after 2nd dose of Pfizer BNT162b2 COVID-19 vaccine [bilirubin 10.5 mg/dL, ALT 1186 U/L, Alk P 243 U/L, ANA 1:160, IgG 3500 mg/dL], biopsy compatible with autoimmune hepatitis and rapid biochemical response to prednisone).
Londoño MC, Gratacós-Ginès J, Sáez-Peñataro J. Another case of autoimmune hepatitis after SARS-CoV-2 vaccination - still casualty? J Hepatol. 2021 Jun 12:S0168-8278(21)00417-7. (41 year old woman [with no history of autoimmune diseases] developed persistent abdominal pain after the first dose of Moderna mRNA1273 COVID-19 vaccine and jaundice 7 days after the second dose [bilirubin 2.3 rising to 8.5 mg/dL, ALT 1312 U/L, Alk P 190 U/L, ANA 1:80, IgG 2080 mg/dL], biopsy compatible with autoimmune hepatitis and prompt response to prednisone therapy).
Tan CK, Wong YJ, Wang LM, Ang TL, Kumar R. (2021). Autoimmune hepatitis following COVID-19 vaccination: True causality or mere association?. J Hepatol. (56 year old woman [with no history of autoimmune diseases] developed marked fatigue after the first dose of Moderna mRNA1273 COVID-19 vaccine and jaundice 5 weeks later [bilirubin 6.0 mg/dL, ALT 1701 U/L, Alk P 298 U/L, ANA and SMA positive, IgG 3260 mg/dL], biopsy compatible with autoimmune hepatitis and improvement while on budesonide therapy).
Clayton-Chubb D, Schneider D, Freeman E, Kemp W, Roberts SK. (2021). Autoimmune hepatitis developing after the ChAdOx1 nCoV-19 (Oxford-AstraZeneca) vaccine. J Hepatol. (36 year old asymptomatic man [with no history of autoimmune diseases] found to have abnormal liver tests 26 days after receiving 1st dose of Astra Zeneca ChAdOx1 COVID-19 vaccine [bilirubin 1.0 rising to 2.2 mg/dL, ALT 1774 mg/dL, Alk P 118 U/L, ANA 1:160, IgG 1280 mg/dL], biopsy compatible with autoimmune hepatitis and response to prednisone therapy).
Rela M, Jothimani D, Vij M, Rajakumar A, Rammohan A. (2021). Auto-immune hepatitis following COVID vaccination. J Autoimmun. (Two cases of jaundice arising 1-2 weeks after receiving Astra Zeneca ChAdOx1 COVID-19 vaccine, 37 year old woman with hypothyroidism and 62 year old man with type 2 diabetes [peak bilirubin 14.9 and 19.2 mg/dL, ALT 1025 and 1094 U/L, ANA 1:80 and negative, INR 2.96 and 4.28], biopsies compatible with autoimmune hepatitis and prompt improvement with prednisone in one patient and progressive liver failure and death in the other).
McShane C, Kiat C, Rigby J, Crosbie Ó. (2021). The mRNA COVID-19 vaccine - A rare trigger of autoimmune hepatitis?. J Hepatol. (71 year old woman [with no history of autoimmune diseases] developed jaundice 4 days after receiving the first dose of Pfizer BNT262b2 COVID-19 vaccine [bilirubin 15.8 mg/dL, ALT 1067 U/L, Alk P 217 U/L, SMA 1:2560, IgG 2177 mg/dL, INR 1.4], biopsy compatible with autoimmune hepatitis and rapid improvement with prednisolone therapy).
Ghielmetti M, Schaufelberger HD, Mieli-Vergani G, Cerny A, Dayer E, Vergani D, Terziroli Beretta-Piccoli B. (2021). Acute autoimmune-like hepatitis with atypical anti-mitochondrial antibody after mRNA COVID-19 vaccination: A novel clinical entity?. J Autoimmun. (63 year old man [with no history of autoimmune diseases] developed jaundice 7 days after receiving first dose of Moderna mRNA1273 COVID-19 vaccine [bilirubin 12.0 mg/dL, ALT 1038 U/L, Alk P 192 U/L, ANA 1:640], biopsy compatible with autoimmune hepatitis and prompt response to prednisone).
Lodato F, Larocca A, D'Errico A, Cennamo V. (2021). An unusual case of acute cholestatic hepatitis after m-RNABNT162b2 (Comirnaty) SARS-CoV-2 vaccine: Coincidence, autoimmunity or drug-related liver injury. J Hepatol. (43 year old man [with no history of autoimmune diseases] developed itching 2 weeks after first and jaundice 2 days after the second dose of Pfizer BNT162b2 COVID-19 vaccine [bilirubin 17.5 rising to 29.1 mg/dL, ALT 52 U/L, Alk P not given, ANA negative, IgG normal], biopsy compatible with autoimmune hepatitis and slow response to prednisone therapy).
Vuille-Lessard É, Montani M, Bosch J, Semmo N. (2021). Autoimmune hepatitis triggered by SARS-CoV-2 vaccination. J Autoimmun. (76 year old woman [with a history of Hashimoto’s thyroiditis] developed fatigue, weight loss and then dark urine starting 2 days after receiving first dose of Moderna mRNA1273 COVID-19 vaccine [bilirubin 3.8 mg/dL, ALT 579 U/L, Alk P 124 U/L, INR 1.23, ANA 1:1280, SMA 1:1280, IgG 3940 mg/dL], biopsy compatible with autoimmune hepatitis and rapid improvement with prednisone and azathioprine with normal enzymes at 4 weeks and no relapse when immunosuppression was stopped).
Ekpanyapong S, Bunchorntavakul C, Reddy KR. (2021). COVID-19 and the liver: Lessons learnt from the East and the West, a year later. J Viral Hepat. (Review of the frequency and pathogenesis of liver manifestations in patients with COVID-19 as well as risks of complications in patients with chronic liver disease, cirrhosis, hepatocellular carcinoma and liver transplant and need for vaccination in these groups).
Fanni D, Saba L, Demontis R, Gerosa C, Chighine A, Nioi M, Suri JS, et al. (2021). Vaccine-induced severe thrombotic thrombocytopenia following COVID-19 vaccination: a report of an autoptic case and review of the literature. Eur Rev Med Pharmacol Sci. (58 year old man developed abdominal pain within 1-2 weeks of receiving the Astra Zeneca ChAdOx1 COVID-19 [platelets 28,000/uL, low fibrinogen, high D-dimer levels], which progressed to multiorgan failure and death within 3 days, autopsy showing major thrombi in the portal and mesenteric veins but microthrombi also in small veins, capillaries and even hepatic sinusoids).
Bril F. (2021). Autoimmune hepatitis developing after coronavirus disease 2019 (COVID-19) vaccine: One or even several swallows do not make a summer. J Hepatol. (Summary of 6 recently published letters describing cases of liver injury after COVID-19 vaccination [mRNA1273 in 3, BNT162b2 in 2 and ChAdOx1 in 1], 4 with first dose and 1 with second, latency 4 to 35 days, bilirubin above 2.5 mg/dL in 4, ALT above 1000 U/L in 5, ANA present in 4, IgG elevations in 3, biopsy suggestive of autoimmune hepatitis and response to corticosteroid therapy in all).
Graça LL, Amaral MJ, Serôdio M, Costa B. (2021). Extensive thrombosis after COVID-19 vaccine: cause or coincidence?. BMJ Case Rep. (62 year old woman developed abdominal pain the day after receiving the first dose of Astra Zeneca ChAdOx1 COVID-19 vaccine with both arterial [hepatic and splenic] and venous thrombosis [inferior vena cava, portal, splenic and mesenteric] with thrombocytosis [788,000/µL] and high levels of D-dimers and mild liver test abnormalities).
Mann R, Sekhon S, Sekhon S. (2021). Drug-Induced Liver Injury After COVID-19 Vaccine. Cureus. (61 year old woman developed nausea, fever, and jaundice 9 days after receiving the Pfizer BNT162b2 COVID-19 vaccine [bilirubin 6.2 mg/dL, ALT 37 U/L, Alk P 207 U/L], which resolved over the next 3 weeks with no therapy and all values were normal 4 months later).
Palla P, Vergadis C, Sakellariou S, Androutsakos T. Letter to the editor: Autoimmune hepatitis after COVID-19 vaccination. A rare adverse effect? Hepatology. 2021 Sep 15. Epub ahead of print. (40 year old woman was found to have aminotransferase elevations 1 month after completing vaccination with Pfizer BNT262b2 COVID-19 vaccination [bilirubin, ALT and Alk P not given; ANA 1:640, IgG 2400 mg/dL], biopsy compatible with autoimmune hepatitis and prompt improvement on starting prednisone).
Dash S, Sirka CS, Mishra S, Viswan P. (2021). COVID-19 vaccine-induced Stevens-Johnson syndrome. Clin Exp Dermatol. (60 year old man developed fever, oral ulcers and rash starting 3 days after receiving the first dose of AstraZeneca ChAdOx1 COVID-19 vaccine [liver test results not reported], which responded rapidly to cyclosporine therapy).
Bakir M, Almeshal H, Alturki R, Obaid S, Almazroo A. (2021). Toxic epidermal necrolysis post COVID-19 vaccination - first reported case. Cureus. (49 year old woman developed fever, fatigue, and headaches followed by rash, blisters and oral ulcers starting 1 week after receipt of the Pfizer BNT162b2 COVID-19 vaccine and ultimately involving more than 30% of her body surface area [ALT 90 U/L, bilirubin and alkaline phosphatase not provided], with lesions healing within 21 days of starting therapy including etanercept).
Elboraey MO, Essa EESF. (2021). Stevens-Johnson syndrome post second dose of Pfizer COVID-19 vaccine: a case report. Oral Surg Oral Med Oral Pathol Oral Radiol. (Middle aged woman developed fever and fatigue followed by skin rash with bullae and mouth ulcers within 5 days of receiving a second injection of Pfizer BNT162b2 vaccine [liver tests not reported], which resolved with corticosteroid therapy).
Asmat H, Fayeye F, Alshakaty H, Patel J. (2021). A rare case of COVID-19 vaccine-induced thrombotic thrombocytopaenia (VITT) involving the veno-splanchnic and pulmonary arterial circulation, from a UK district general hospital. BMJ Case Rep. (47 year old woman developed headaches 5 days after receiving Astra Zeneca ChAdOx1 COVID-19 vaccine [platelets 13,000/µL, ALT 57 U/L, Alk P 138 U/L, bilirubin not given, elevations in D-dimer levels, anti-PF4 positive], but imaging of the brain showed no thromboses; when she later developed abdominal pain, imaging showed evidence of portal and mesenteric vein thromboses and pulmonary emboli, and she improved after receiving IVIG and oral anticoagulants).
Thomas SJ, Moreira ED, Kitchin N, Absalon J, Gurtman A, Lockhart S, Perez JL, et al. (2021). C4591001 Clinical Trial Group. Safety and efficacy of the BNT162b2 mRNA Covid-19 vaccine through 6 months. N Engl J Med. (Among 44,165 participants [ages 16 years and older] given BNT162b2 COVID-19 vaccine or placebo [initially reported in Pollack 2020], vaccine efficacy at 6 months was 91.3% and had gradually declined over time, while serious adverse events were reported in 1.2% vs 0.7%, but there were no new events attributable to vaccine, no cases of myocarditis or no serious hepatic adverse events).
El Sahly HM, Baden LR, Essink B, Doblecki-Lewis S, Martin JM, Anderson EJ, Campbell TB, et al., COVE Study Group. (2021). Efficacy of the mRNA-1273 SARS-CoV-2 vaccine at completion of blinded phase. N Engl J Med. (Among 30,415 adults [ages 18 and over] given mRNA-1723 COVID-19 vaccine or placebo [initially reported in Baden 2021], vaccine efficacy at a median follow up of 5.3 months was 93.2% , while unsolicited adverse events arose in 42% vs 43%, were serious in 1.8% vs 1.9%, included Bell’s palsy in 3 vs 5 subjects [both <0.1%], thrombotic events in 47 vs 43 subjects [both <0.3%], but there were no hepatic serious adverse events and no cases of myocarditis).
Heath PT, Galiza EP, Baxter DN, Boffito M, Browne D, Burns F, Chadwick DR, et al. (2021). 2019nCoV-302 Study Group. Safety and efficacy of NVX-CoV2373 Covid-19 vaccine. N Engl J Med. (Among 15,187 adults [ages 18 to 84] given the Novavax CoV2373 COVID-19 vaccine or placebo, vaccine efficacy was 89.7%, while local adverse events arose in 46% vs 36% with the first injection and 64% vs 30% with the second, solicited systemic adverse events arose in 58% vs 18% with the first and 80% vs 16% with the second, no patient had anaphylaxis; unsolicited adverse events occurred in 25% vs 21% and were severe in 1.0% vs 0.8%, severe events including one vaccinee with myocarditis and one placebo recipient with “liver injury”).
James J, Jose J, Gafoor VA, Smita B, Balaram N. (2021). Guillain-Barré syndrome following ChAdOx1 nCoV-19 COVID-19 vaccination: A case series. Neurol Clin Neurosci. (Report of 3 cases of Guillain-Barré syndrome arising within 16-18 days of receiving the first dose of AstraZeneca ChAdOx1 COVID-19 vaccine; liver test results were not provided).
Falsey AR, Sobieszczyk ME, Hirsch I, Sproule S, Robb ML, Corey L, Neuzil KM, et al. (2021). AstraZeneca AZD1222 Clinical Study Group. Phase 3 safety and efficacy of AZD1222 (ChAdOx1 nCoV-19) Covid-19 vaccine. N Engl J Med. (Among 34,117 adults receiving the AstraZeneca AZD1222 COVID-19 vaccine or placebo, vaccine efficacy was 74% [disease occurring in 0.4% vs 1.5% of participants], and while total adverse events were more frequent with vaccine [41% vs 30%], serious adverse event rates were similar [both 0.5%] and among the list of serious events arising within 28 days of the injections, there were no instances of thrombotic thrombocytopenia or acute liver injury).
Jara A, Undurraga EA, González C, Paredes F, Fontecilla T, Jara G, Pizarro A, et al. (2021). Effectiveness of an inactivated SARS-CoV-2 vaccine in Chile. N Engl J Med. (In a nationwide analysis of Sinovac’s inactivated COVID-19 vaccine[Corona Vac] in Chile, among a total population of approximately 10.2 million persons, 10.2 million received two doses of vaccine and 0.5 million received one dose; the vaccine efficacy was 65.9% with two and 15.6% with one dose, adverse reactions were similar to those of other COVID-19 vaccines, no mention of ALT elevations or hepatotoxicity).
Barda N, Dagan N, Ben-Shlomo Y, Kepten E, Waxman J, Ohana R, Hernán MA, et al. (2021). Safety of the BNT162b2 mRNA Covid-19 vaccine in a nationwide setting. N Engl J Med. (Among 884,825 Israel citizens who received the BNT162b2 mRNA COVID-19 vaccine (Pfizer) and a similar number of controls as well as 173,106 patients with SARS-CoV-2 infection and 173,106 uninfected controls, adverse events that were more frequent within 42 days of vaccination included myocarditis [relative risk = 3.24], lymphadenopathy [2.43], appendicitis [1.40] and herpes zoster infection [1.43], although all but lymphadenopathy was even more frequent with SARS-CoV-2 infection; there was no increase in deep vein or other thromboses, intracerebral bleeding, Bell’s palsy, or renal disease after vaccination in comparison to control and higher rates of these after SARS-CoV-2 infection; no mention of ALT elevations or autoimmune hepatitis ).
Shroff H, Satapathy SK, Crawford JM, Todd NJ, VanWagner LB. Liver injury following SARS-CoV-2 vaccination: A multicenter case series. J Hepatol. 2021:S0168-8278(21)01953-X. Epub ahead of print. (Prospective US registry of hepatic adverse events following COVID-19 vaccination identified 16 patients who developed liver test abnormalities 5-46 days after the first [n=4] or second [n=12] inoculation of the BNT162b2 mRNA [Pfizer: n=12] or mRNA-1723 [Moderna: n=4] vaccine, of which 13 had a hepatocellular and 3 mixed or cholestatic pattern, 6 with preexisting liver disease, 9 with bilirubin above 2.5 mg/dL but only 3 with bilirubin above 10 mg/dL, 8 treated with corticosteroids, none fatal, and all fully recovered or “recovering”).